# Mobocertinib

## OVERVIEW

### Introduction

Mobocertinib is an oral tyrosine kinase receptor inhibitor that targets the epidermal growth factor receptor (EGFR) and was given accelerated approved for use in refractory, advanced or metastatic non-small cell lung cancer with EGFR exon 20 insertion mutations in 2021, but was subsequently withdrawn from use in October 2023 because of lack of efficacy found in a subsequent phase 3 controlled trial. Serum aminotransferase elevations occurred in 20% of patients treated with mobocertinib, but no episodes of clinically apparent liver injury with jaundice have been reported with its use.

### Background

Mobocertinib (moe” boe cer’ ti nib) is an orally available tyrosine kinase inhibitor that targets both wild type and mutant forms of the epidermal growth factor receptor (EGFR), which are found in patients with highly treated, resistant forms of advanced or metastatic cancer such as non-small cell lung cancer (NSCLC). Mobocertinib has potent specificity against exon 20 insertion mutations of EGFR and its use is generally limited to NSCLC with these highly resistant mutants after therapy with first- or second-line therapies for NSCLC such as platinum based regimens and other EGFR inhibitors. Mobocertinib was granted accelerated approval in the United States in 2021 for adults with refractory, advanced or metastatic NSCLC with documented EGFR exon 20 insertion mutations, the first oral drug to be approved for this indication. Mobocertinib became available in capsules of 40 mg under the brand name Exkivity. The recommended starting dose was 160 mg orally once daily to be continued until disease progression or unacceptable toxicity. Mobocertinib was voluntarily withdrawn from use by the sponsor after initial results from a phase 3 clinical trial failed to show a significant effect on progression-free survival. Side effects were common during mobocertinib therapy, requiring dose interruptions in half of treated patients, dose reductions in 25%, and permanent discontinuation in 17%. Common adverse events included diarrhea, nausea, vomiting, decreased appetite, fatigue, pruritis, rash, paronychia, musculoskeletal pains, and stomatitis. Uncommon but potentially severe adverse events included prolongation of the QTc interval, interstitial lung disease, cardiac toxicity, severe diarrhea, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of mobocertinib in patients with NSCLC harboring the exon 20 insertion mutation in EGRF, ALT elevations arose in 22% of patients but were usually self-limited and mild. ALT elevations above 5 times the upper limit of normal (ULN) were uncommon, being found in 2% to 3% of treated patients. In the open label trials supporting the approval of mobocertinib, there were no instances of clinically apparent liver injury, hepatic failure, or deaths from liver injury. Since the accelerated approval of mobocertinib in 2021 there were no published case reports of clinically apparent liver injury with jaundice.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from mobocertinib is unknown, but the pattern of abnormalities suggests some degree of direct toxicity. Mobocertinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

### Outcome and Management

The product label for mobocertinib does not recommend regular monitoring of liver tests, but if serum aminotransferase levels above 5 times the ULN are identified, therapy should be held until levels fall into the normal or near normal range, at which point therapy can be resumed at the same or a reduced dose as clinically indicated and with continued monitoring. Cross sensitivity to liver injury is uncommon among the antineoplastic small molecule enzyme and receptor inhibitors, but there is no information on shared adverse event sensitivity of mobocertinib with other antineoplastic tyrosine kinase receptor inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Small Molecule Inhibitors of EGFR: Afatinib, Dacomitinib, Erlotinib, Gefitinib, Osimertinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mobocertinib – Exkivity®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mobocertinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mobocertinib | 1847461-43-1 | C32-H39-N7-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 30 October 2023

Abbreviations: EGFR, epidermal growth factor receptor; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss mobocertinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215310Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of mobocertinib; describes the adverse events observed in a pooled safety population of 114 patients that included ALT elevations 22% which were above 5 times ULN in only 2.7% [n=3], and included one temporary interruption because of a concurrent ALT and bilirubin elevation that resolved rapidly and the patient then tolerated treatment at a lower dose [120 mg daily]).
Riely GJ, Neal JW, Camidge DR, Spira AI, Piotrowska Z, Costa DB, Tsao AS, et al. Activity and safety of mobocertinib (TAK-788) in previously treated non-small cell lung cancer with EGFR exon 20 insertion mutations from a phase I/II trial. Cancer Discov. 2021;11:1688-1699. (Among 136 patients with advanced refractory NSCLC with EGFR mutations treated with mobocertinib [160 mg daily] in early phase studies, adverse events included diarrhea [83%], nausea [43%], rash [33%], vomiting [26%), decreased appetite [21%], stomatitis [21%], and fatigue [21%]; no mention of ALT elevations or hepatotoxicity). 33632775
Markham A. Mobocertinib: first approval. Drugs. 2021;81:2069-2074. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of mobocertinib shortly after its accelerated approval in the US mentions that serious adverse reactions occurred in 46% of patients, permanent discontinuations in 17%, and ALT elevations in 22% which were above 5 times ULN in 2.7%). 34716908
Zhou C, Ramalingam SS, Kim TM, Kim SW, Yang JC, Riely GJ, Mekhail T, et al. Treatment outcomes and safety of mobocertinib in platinum-pretreated patients with EGFR exon 20 insertion-positive metastatic non-small cell lung cancer: a phase 1/2 open-label nonrandomized clinical trial. JAMA Oncol. 2021;7:e214761. (Among 210 patients with advanced refractory NSCLC with EGFR exon 20 insertion mutations treated with mobocertinib in two studies, ALT elevations arose in 9% [n=19] and were above 5 times ULN in 1% [n=2], and there were no permanent discontinuations or deaths attributed to liver injury). 34647988
Roskoski R Jr. Properties of FDA-approved small molecule protein kinase inhibitors: a 2022 update. Pharmacol Res. 2022;175:106037. (Comprehensive review of human protein kinases and the 68 small molecular inhibitors that have been approved for use in neoplastic [n=58], autoimmune, cardiovascular, neurologic, and inflammatory diseases which can be categorized as serine/threonine [n=12], tyrosine [n=42], or dual [n=4] and as tyrosine receptor [n=39] or nonreceptor [n=13] inhibitors; mobocertinib is a tyrosine kinase receptor inhibitor that was designed to form a covalent bond with an amino acid [C797] in the EGFR exon 20 insertion and thus have increased specificity for the mutant form). 34921994
Mobocertinib (Exkivity) for non-small cell lung cancer. Med Lett Drugs Ther. 2022;64:e197-e198. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of mobocertinib shortly after its accelerated approval for use in patients with NSCLC with EGFR exon 20 insertion mutations, discusses common adverse reactions and rare instances of QTc interval prolongation but does not mention ALT elevations or hepatotoxicity). 36397196
Duke ES, Stapleford L, Drezner N, Amatya AK, Mishra-Kalyani PS, Shen YL, Maxfield K, et al. FDA approval summary: mobocertinib for metastatic non-small cell lung cancer with EGFR exon 20 insertion mutations. Clin Cancer Res. 2023;29:508-512. (Summary of the data on safety and efficacy of mobocertinib that led to its accelerated approval by the FDA mentions that the common adverse effects included diarrhea, rash, nausea, stomatitis, vomiting, decreased appetite, paronychia, fatigue, dry skin, and musculoskeletal pain as well as common laboratory abnormalities of decreased lymphocytes, hemoglobin, potassium and magnesium, and increased amylase, lipase, and creatinine levels, but does not mention ALT elevations or hepatotoxicity). 36112541
Takeda. https://www.takeda.com/newsroom/newsreleases/2023/Takeda-Provides-Update-on-EXKIVITY-mobocertinib/ (October 2, 2023 news report and announcement from Takeda mentions that the sponsor has voluntarily withdrawn mobocertinib as therapy of adults with NSCLC and EGFR exon 20 insertion mutations because a recently completed phase 3 trial failed to demonstrate prolongation of progression free survival: no details of the response rates or adverse events provided).

## OTHER REFERENCE LINKS

Recent References on Mobocertinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mobocertinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Mobocertinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mobocertinib)